# Clinical Course and Diagnosis of Drug Induced Liver Disease

The clinical symptoms, signs and patterns of liver test abnormalities of drug induced liver injury can mimic virtually any form of liver disease – from acute viral hepatitis to gall stone disease with biliary obstruction, acute fatty liver and even chronic hepatitis and cirrhosis. There are no specific findings or laboratory tests that definitely prove that a suspected drug, nutritional supplement or herbal product is the cause of the injury. Drug induced liver injury is a diagnosis of exclusion and relies upon clinical judgment and knowledge about the potential of the agent to cause liver injury versus the likelihood that other forms of liver diseases are the cause. For some medications, the pattern of clinical presentation and liver test abnormalities strongly suggest that the drug is the cause of the liver injury, but ultimately the more common causes of liver disease must be ruled out before a drug is considered the likely cause.

In judging the likelihood of drug induced liver disease, six features are important:

- the onset after starting the drug: time to onset [latency]
- the recovery after stopping the drug: time to recovery [challenge]
- the clinical pattern: injury pattern and clinical phenotype [phenotype]
- exclusion of other causes of liver injury [differential diagnosis]
- whether the drug is a known cause of liver injury [likelihood]
- response to reexposure, whether inadvertent or intentional [rechallenge]

## Time to Onset

The time to onset, incubation period or latency represents the time from the first day of drug therapy to onset of liver injury. Typically, the latency of drug induced liver injury is between 5 days and 3 months of starting a medication, but there are important exceptions. A very short incubation period of 24 to 72 hours can occur with hypersensitivity reactions, particularly upon reexposure to the medication (sulfonamides, macrolide antibiotics). Furthermore, there are drugs that typically cause liver injury 3 to 12 months after starting (isoniazid, flutamide) and others for which the liver injury arises or becomes clinically evident after years of use (minocycline, amiodarone, nitrofurantoin).

Measurement of the time to onset may be difficult. The latency is usually measured from the time of starting to the time of onset of jaundice, dark urine or detection of an elevation in serum bilirubin; but in other situations latency is measured to the time of the first symptom, which might be fatigue, weakness, nausea, poor appetite, abdominal pain, fever, rash or itching. Finally, drug induced liver injury may occur without symptoms or jaundice and be identified only when blood test abnormalities are found. Whatever feature is used to determine the time to onset, it should be clearly stated, either as time to onset of symptoms, time to onset of jaundice, or time to first laboratory test abnormalities. Finally, the latency may not be known or may be indefinite because the exact day that the medication was started is not known or the medication was used intermittently.

## Time to Recovery

The time to recovery represents the time from stopping the suspected drug to full recovery from liver injury. Usually, drug induced liver injury starts to resolve within a few days to a week of stopping therapy. In some instances, the resolution is quite rapid (acetaminophen, niacin), but in most cases, the injury does not fully resolve for several weeks or months. Indeed, the liver injury can be prolonged and even persistent (chronic). In the typical case, however, improvement starts within a week or two of stopping therapy, and the injury resolves completely within 2 to 3 months. The timing of recovery in relation to stopping the drug provides support for the agent being the cause of the injury. Unfortunately, in some instances, the time to recovery may not be known or may be indefinite because laboratory testing or recording of symptoms were not done or were done infrequently. In managing patients with drug induced liver injury, it is important to document full recovery.

## Clinical Pattern

The clinical pattern is perhaps the most important and complex component in deciding whether the medication, herbal or dietary supplement was the cause of the liver injury. The presence of a typical clinical pattern depends, of course, on previous reports of liver injury associated with the agent. When such information is available, presentation with a clinical pattern that is similar to what has been reported in the literature provides compelling evidence implicating that agent. The clinical pattern can be categorized by the injury pattern (whether hepatocellular, cholestatic or mixed) or by an overall "clinical phenotype" which is based on several elements and its resemblance to other types of liver injury such as acute hepatitis, cholangitis, autoimmune hepatitis, cirrhosis or nodular regenerative hyperplasia.

## Injury Pattern

Drug induced liver disease can be classified into three patterns of injury: hepatocellular, cholestatic, and mixed hepatocellular-cholestatic. These designations refer to histologic features of injury, but are usually defined based upon the pattern of serum enzyme elevations.

Hepatocellular injury. Drug induced liver disease that resembles acute viral hepatitis is typified by a prominent hepatocellular pattern of injury. Liver biopsy, if available, usually shows marked liver cell necrosis and inflammation with only mild bile stasis, at least in the early stages. Hepatocellular injury can also be suggested by clinical and laboratory features. If present, symptoms of fatigue and weakness predominate. Serum alanine and aspartate aminotransferase (ALT and AST) levels typically are markedly elevated (usually >10-fold), while the alkaline phosphatase or gamma glutamyl transpeptidase (GGT) are only modestly increased. An “R” ratio of ALT to alkaline phosphatase (both expressed as multiples of the upper limit of the normal range) of 5 or more is often used to define a hepatocellular pattern of injury, but may not always be accurate. Agents that typically give a hepatocellular pattern of injury include isoniazid, green tea, nitrofurantoin and methyldopa.

Cholestatic injury. A cholestatic picture of drug induced liver injury resembles bile duct obstruction or choledocholithiasis. The liver biopsy findings are generally of bile stasis, portal inflammation and proliferation or injury of bile ducts and ductules. Clinically, symptoms of jaundice and itching predominate. Right upper quadrant pain may be present. Serum alkaline phosphatase and GGT levels are prominently elevated, while ALT and AST levels are minimally or modestly increased. The bilirubin is increased more than would be expected from the degree of liver injury. An R ratio of ALT to alkaline phosphatase (both expressed as multiples of the upper limit of the normal range) of 2 or less is used to define a cholestatic pattern of injury, but may not always be accurate. Drugs that typically cause a cholestatic liver injury pattern include amoxicillin/clavulanate (Augmentin), ciprofloxacin and the sulfonylureas.

Mixed hepatocellular-cholestatic injury. A mixture of hepatocellular and cholestatic injury is typical of many drugs and, indeed, is the pattern that is most characteristic of drug induced liver injury, occurring rarely in other forms of acute liver disease. In cases of mixed injury, liver biopsy shows prominent hepatocyte necrosis and inflammation accompanied by marked bile stasis. Symptoms may include both fatigue and itching, and laboratory tests show similar elevations in serum ALT and alkaline phosphatase. An R ratio of ALT to alkaline phosphatase (both expressed as multiples of the upper limit of the normal range) between 2 and 5 is used to defined a mixed pattern of injury. Drugs that cause a mixed hepatocellular-cholestatic pattern of injury include the sulfonamides, phenytoin and enalopril.

## Clinical Phenotype

In addition, drug induced liver injury can be categorized by an overall clinical pattern and course of injury into at least twelve "phenotypes". These phenotypes overlap to some degree with the pattern of injury (hepatocellular, cholestatic, mixed) and include: acute hepatic necrosis, acute (hepatocellular) hepatitis, cholestatic hepatitis, mixed hepatitis, serum enzyme elevations without jaundice, bland cholestasis, acute fatty liver with lactic acidosis, nonalcoholic fatty liver, chronic hepatitis, sinusoidal obstruction syndrome, nodular regenerative hyperplasia, and liver tumors, such as hepatic adenoma and hepatocellular carcinoma. In addition, characteristic features or outcomes are often assigned to each phenotype such as immunoallergic features, autoimmune features, acute liver failure, vanishing bile duct syndrome and cirrhosis. Each of these phenotypes is described briefly below and links are given to more comprehensive descriptions as well as case examples, liver histology and selected references.

Acute hepatic necrosis. Drug induced liver injury can resemble an acute ischemic or toxic injury to the liver with rapid onset of hepatocellular injury and marked elevations in serum ALT and just as rapid decline once the agent is stopped. Signs of hepatic dysfunction and failure occur early, even before the onset of jaundice, which is typically mild. Other organs can be involved including kidney, lung, bone marrow, and brain. The time to onset after exposure is usually rapid (within days) with initial symptoms of nausea, vomiting, and abdominal pain followed by mental confusion, somnilence and coma. The liver enzyme pattern is typically hepatocellular and serum lactic dehydrogenase (LDH) and creatine kinase (CPK) may also be high. If done, liver biopsy shows a somewhat bland, centrolobular necrosis, which is also typical of ischemic injury to the liver (from shock or hypoxia). The injury can be fatal, but recovery in nonfatal cases is rapid. Typical agents that cause acute hepatic necrosis include high doses of acetaminophen, aspirin, niacin, and intravenous amiodarone. (See Acute hepatic necrosis)

Acute hepatitis. Drug induced liver injury can resemble acute viral hepatitis with prominence of hepatocellular injury and marked elevations in serum ALT. Symptoms may also be identical those of viral hepatitis, with a prodomal period of fatigue, nausea and poor appetite followed by abdominal discomfort, dark urine and jaundice. The liver enzyme pattern is typically hepatocellular. Even the liver biopsy findings may resemble hepatitis due to a viral infection. In these situations, exclusion of infection with hepatitis A, B and C (and sometimes hepatitis E) is necessary. Typical agents that cause an acute hepatitis-like syndrome include isoniazid, ketoconazole and flutamide. (See Acute hepatitis)

Cholestatic and mixed hepatitis. The most characteristic clinical phenotypes of drug induced liver disease are a mild to moderate cholestatic or mixed hepatitis, which usually arises 2 to 12 weeks after starting a medication. Alkaline phosphatase and gamma glutamyltranspeptidase levels are prominently elevated and serum ALT levels either modestly (cholestatic injury) or only moderately (mixed injury) elevated. In some instances, the pattern of enzyme elevations can be hepatocellular at the onset of illness. The cholestasis can be mild and short lived or severe and prolonged. Itching is a prominent symptom. Cholestatic hepatitis is typical of the liver injury caused by amoxicillin/clavuanate and sulfonylureas. Mixed hepatitis is typical of many medications including phenytoin, sulfonamides, macrolide antibiotics and enalapril. (See Cholestatic hepatitis and Mixed hepatitis)

Serum enzyme elevations without jaundice. Actually, the most common pattern of drug induced liver injury is an elevation in serum aminotransferase or alkaline phosphatase (or both) levels without jaundice and usually without symptoms. The frequency of this form of hepatotoxicity ranges widely, from less than 1% to as high as 50% to 70% of patients, depending upon the medication and the frequency of monitoring for liver enzyme abnormalities. (See Serum enzyme elevations without jaundice)

Pure or bland cholestasis. The finding of cholestasis without or with only modest liver cell injury is a rare form of drug induced liver disease. Itching and jaundice are prominent, but, otherwise, patients typically feel well. Serum alkaline phosphatase and ALT levels may be normal or minimally (less that two-fold) elevated, particularly at the peak of symptoms and jaundice. At the onset, ALT levels may be more prominently elevated (3 to 10 fold) and in more severe instances, serum alkaline phosphatase may rise above 2 fold. Pure or bland cholestasis is the characteristic form of liver injury caused by estrogenic and anabolic steroids and can occur with illicit use of muscle building regimens and more rarely with the thioguanines such as azathioprine and mercaptopurine. (See Pure or bland cholestasis)

Acute fatty liver with lactic acidosis. This is a rare and often severe form of drug induced liver injury that is caused by medications that alter fat metabolism and inhibit mitochondrial function. After a prodromal period of nonspecific symptoms and minimal serum enzyme elevations, patients present with signs of liver failure, such as coagulopathy, hyperammonemia and lactic acidosis. Initially, liver biopsy histology shows microvesicular (small droplet) fat and little evidence of injury. Later there is appearance of macrovesciular (large droplet) fat and liver cell injury. Drugs that cause acute microvesicular fatty liver include antiviral agents such as fialuridine, zidovudine, didanosine and stavudine, and the antibiotics tetracycline and linezolid when given intravenously. (See Acute fatty liver with lactic acidosis)

Nonalcoholic fatty liver disease. This is an uncommon form of drug induced liver disease and often difficult to separate from the spontaneous, metabolic form that occurs in patients who are overweight or have diabetes and the metabolic syndrome. The onset is insidious and often without symptoms or signs of liver disease. Serum aminotransferase levels are generally mildly but persistently elevated. Ultrasound or other forms of hepatic imaging may suggest steatosis. A liver biopsy is diagnostic showing steatosis, inflammation and ballooning degeneration, which are typical of alcoholic and nonalcoholic steatohepatitis. Nonalcoholic fatty liver disease due to medications typically arises months to years after initiation of therapy and is actually a chronic rather than acute form of liver injury. Drugs associated with fatty liver injury include methotrexate and tamoxifen. (See Nonalcoholic fatty liver disease)

Chronic hepatitis. Liver injury that persists for at least six months is generally considered chronic. Most cases of drug induced liver disease resolve within a few weeks or months after the medication is stopped. However, in up to 5% of cases there is evidence of peristent liver injury. Chronic liver injury due to medications takes several forms. In many cases, it merely represents a slow resolution of a severe acute injury; in other instances the medication possibly triggered a chronic liver disease, such as autoimmune hepatitis or primary biliary cirrhosis; finally, in rare cases active liver injury persists for unknown reasons. (See Chronic hepatitis)

Sinusoidal obstruction syndrome. Medications that injure non-parenchymal and endothelial cells in the liver can cause a sinusoidal obstruction syndrome, also known as veno-occlusive disease. This form of drug induced liver injury is rare but can be severe and result in acute liver failure. Symptoms of abdominal pain and swelling are typical, with early development of weight gain, fluid retention and ascites. Serum ALT levels tend to be high, with the enzyme pattern suggesting hepatocellular injury. Drugs that cause sinusoidal obstructive syndrome include many chemotherapeutic and radio-mimetic agents, particularly busulfan (used for myeloablation before bone marrow transplantation), as well as environmental toxins and phytotoxins such as the vinca alkaloids found in Jamaican “bush” tea. (See Sinusoidal obstruction syndrome)

Nodular regenerative hyperplasia. Medications can cause a subtle injury to the liver that leads to regenerative nodules with minimal or no fibrosis, but resulting in portal hypertension and liver dysfunction. This form of drug induced liver disease is rare and occurs largely with long term use of cytotoxic agents. The underlying mechanism is not know, but it probably the result of chronic injury to endothelial cells in the liver. Patients usually have mild serum enzyme elevations and present either with mild jaundice and hepatomegaly or with signs of portal hypertension. Nodular regenerative hyperplasia can be progressive and lead to liver failure. Medications associated with this syndrome include azathioprine, thioguanine and oxaliplatin. (See Nodular regenerative hyperplasia)

Liver tumors and cancer. Medications are very rare, but fairly well documented causes of hepatic adenoma, hepatocellular carcinoma and angiosarcoma of the liver. Liver tumors are generally the result of long term therapy and are usually associated with chronic hepatic injury or growth stimulation. Hepatic adenomas have been linked to long term estrogen use (particularly in high doses); hepatic angiosarcoma to the no-longer-used radiologic contrast agent thorotrast; and hepatocellular carcinoma to long term androgenic steroid use. In most instances, the clinical presentation is usually with a liver mass or abdominal discomfort and rarely with hepatic rupture. Some tumors are identified incidentally by imaging of the liver for other reasons. (See Liver tumors)

Immunoallergic hepatitis. Cases of drug induced liver injury presenting with immunologic or allergic manifestations such as fever, rash, arthralgias and eosinophilia are frequently referred to as “immunoallergic” hepatitis. Severe cases may be life-threatening and be accompanied by Stevens-Johnson syndrome. Immunoallergic forms of drug induced liver disease tend to have a short latency period (within 30 days of starting the medication) and an abrupt onset. The pattern of injury may be cholestatic, hepatocellular or mixed. Drugs linked to immunoallergic hepatitis include sulfonamides, sulindac, phenytoin and ciprofloxacin. (See Immunoallergic hepatitis)

Autoimmune hepatitis. Drug induced liver injury can present with clinical syndrome of chronic hepatitis with autoimmune features. Symptoms may be vague and nonspecific, but a distinctive hepatocellular pattern of serum enzyme elevations accompanied by presence of high titers of antinuclear or smooth muscle antibody and high immunoglobulin levels are typical. The latency period to development of the liver injury tends to be long (months or years). Liver histology may resemble autoimmune hepatitis, but symptoms and laboratory test abnormalities usually resolve once the medication is stopped. Drugs associated with autoimmune hepatitis include methyldopa, nitrofurantoin, minocycline, hydralazine and fenofibrate. (See Autoimmune hepatitis)

Acute liver failure. Drug induced liver injury can be severe and lead to liver failure and death. The diagnosis of acute liver failure rests on the finding of severe liver injury, coagulopathy (prolonged prothrombin time) and appearance of symptoms or signs of hepatic encephalopathy. Acute liver failure usually represents the severe cases of drug induced acute hepatitis-like injury. Medications commonly linked to acute liver failure include diclofenac, isoniazid, troglitazone and telithromycin. (See Acute liver failure)

Vanishing bile duct syndrome. The most striking example of chronic injury after acute drug induced liver disease is the vanishing bile duct syndrome (VBDS). VBDS typically arises after an episode of acute cholestatic liver injury that does not fully resolve. The small intra- and interlobular bile ducts are injured and gradually lost, causing cholestasis and "ductopenia." The loss of bile ducts can be transient and ultimately resolve over several months or years, or can be progressive and result in severe, unremitting cholestasis with variable degrees of jaundice, pruritus and hyperlipidemia. If severe, vanishing bile duct syndrome can lead to biliary cirrhosis and hepatic failure, death or need for liver transplantation within 6 to 24 months of onset. Medications associated with vanishing bile duct syndrome include amoxicillin-clavulanate, nonsteroidal antiinflammatory agents, sulfonamides, and the aromatic anticonvulsants. (See Vanishing bile duct syndrome)

Cirrhosis. Drug induced liver disease is a rare cause of cirrhosis, but instances of advanced chronic liver disease have been reported due to medications. Most of these examples probably represent chronic exposure to a medication with an unrecognized acute or chronic presentation, such as with chronic hepatitis or fatty liver disease. Medications associated with cirrhosis include methyldopa, amiodarone, valproate and methotrexate. (See Cirrhosis)

## Exclusion of Other Diagnoses

The final important element in diagnosis of drug induced liver disease is exclusion of other diagnoses. The clinical signature often dictates which liver diseases are most important to exclude. A basic approach to ruling out other liver conditions in a patient suspected of having drug induced liver disease would include:

A careful history, focusing on:

- Risk factors for viral hepatitis
- Alcohol use
- Weight gain
- History of autoimmune disease
- History of cardiac failure, shock, or septicemia
- History of all drug intake, including time of starting and stopping prescription and nonprescription (over-the-counter) drugs and herbals within the previous 3 months

Laboratory test results (and diagnoses to exclude):

- IgM anti-HAV (hepatitis A)
- HBsAg or IgM anti-HBc or both (hepatitis B)
- Anti-HCV or HCV RNA or both (hepatitis C)
- Antinuclear antibody (ANA) and globulin levels (autoimmune hepatitis)
- Ultrasound or other radiological visualization of gallbladder and biliary system (gallstones and obstructive jaundice), and
- Ultrasound characterization of liver quality (alcoholic and nonalcoholic fatty liver disease)

In some instances, the more uncommon forms of liver disease need to be excluded such as hepatitis E, mononucleosis, primary sclerosing cholangitis, primary biliary cirrhosis, Wilson disease, ischemic hepatitis, jaundice of sepsis, and benign postoperative cholestasis. Most of these conditions are either rare (hepatitis E), cause chronic liver disease (sclerosing cholangitis, primary biliary cirrhosis, Wilson disease), or occur in special situations (following episodes of shock, anoxia, surgery or sepsis). Nevertheless, there is no form of acute or chronic liver disease that cannot be mimicked by drug induced liver injury.

## Known Cause of Liver Injury

The diagnosis of drug induced liver disease is made easier if they suspected agent is known to cause liver injury. Thus, knowledge of the field and literature is necessary to reliably assign causality to a medication in the face of an acute liver injury. The clinical signature often dictates which medications are most likely the culprit. The large number of medications used in modern medicine and the constant introduction of new agents makes it difficult to be fully knowledgeable about the potential of all medications to cause liver injury. The LiverTox website offers a means of overcoming some of these difficulties by providing a brief description of the hepatotoxicity of a wide variety of commonly used medications. Importantly, the likelihood that a medication causes liver injury is helpful in weighing the evidence for or against drug induced liver injury and the medications described in the LiverTox website are classified by this likelihood from definite, known hepatotoxic agents to those that are considered without hepatoxic potential.

## Response to Reexposure

Reexposure or rechallenge of a patient to a medication or agent thought to be responsible for drug induced liver injury is usually not advisable. Reexposure can lead to the rapid recurrence of the liver injury, possibly with greater severity and a poor outcome, even death. In very special situations, deliberate rechallenge may be warranted, particularly if the medication is considered life saving or necessary and the initial injury was mild, rapidly reversed upon stopping and atypical for that agent. If several drugs are implicated in causing the liver injury, judicious reintroduction of the agents thought to be least likely the cause may be appropriate. In addition, inadvertent reexposure can occur in a patient who restarts the medication either by accident or because of a misunderstanding of the cause of the liver injury. The reappearance of liver injury with reexposure or rechallenge is perhaps the most convincing evidence for a medication being the cause of the hepatotoxicity. A history of liver injury or an allergic response to a structurally related medication or dietary supplement is also supportive of a diagnosis of drug induced liver injury.

## Complexities in Making Diagnosis

Finally, it should be stressed that most cases of drug induced liver injury are complex and may be difficult to attribute to the suspect drug. In many instances, multiple drugs are taken and the timing of onset of liver injury and timing of initiation of the competing drugs may be unclear from the medical history. Furthermore, other possible causes of liver injury are often present, such as a history of exposure to hepatitis, excessive alcohol intake, or multiple other medical conditions, including underlying chronic liver disease. Cases described in the literature are often not typical, as they are chosen because they clearly and unequivocally implicate the medication. In clinical practice, however, most cases are complex and difficult to attribute definitively to a single drug.

Liver Biopsy